# Slimquick

## OVERVIEW

### Introduction

SLIMQUICK is a popular, proprietary line of multi-ingredient nutritional supplements (MINS) marketed as weight loss products and sold widely in pharmacies and grocery stores as well on the internet. The major ingredients in the products include green tea extract, caffeine and various herbal, fruit and vegetable extracts. There have been rare reports of clinically apparent liver injury in patients taking SLIMQUICK products, the majority of which had clinical features suggestive of green tea hepatotoxicity.

### Background

SLIMQUICK is a proprietary product name for an array of multi-ingredient herbal and nutritional supplements (MINS) marketed as aids in weight loss. The SLIMQUICK brand is currently produced by SLIMQUICK Laboratories (Wilmington, DE). The constituents of the various SLIMQUICK products vary, but the main ingredients are green tea, caffeine and extracts of various botanical agents (Rhodiola rosea, Capsicum annum, Chaste tree, turmeric and ginger) as well as several fruit and vegetable extracts (pomegranate, grape, cocoa, pepper). The ingredients and their concentrations in some of the products have been modified over time.

A selection of common SLIMQUICK products that are currently marketed are given in the Table below with a listing of their ingredients as provided in the product labels shown on the official SLIMQUICK website. Because the products are considered nutritional supplements they are not subject to the usual evaluation of efficacy and safety given to medications. However, all nutritional supplements are subject to rules regarding purity and good manufacturing practices. Nutritional supplements are not recommended for specific medical conditions, but can be advertised as being supportive of general health or a specific tissue or organ health. These multi-ingredient products appear to be generally safe and well tolerated, but prospective studies of their efficacy, tolerance and safety have not been published. Thus, it is not clear whether use of SLIMQUICK products leads to more weight loss than would occur with diet and exercise and if weight loss occurs, what component of the product is responsible. While the product labels list the major ingredients, they provide total concentrations per serving (which may be 2 or 3 capsules or gummies) rather that the concentrations of each specific ingredient.

### SLIMQUICK® – Selected Products for Weight Loss

### (September 2021)

Product Name | Major Listed Ingredients
SLIMQUICK Pure Regular Strength 6 Ways Complex | 455 mg: Caffeine, Rhodiola rosea root extract, Chaste Tree fruit extract [Vitex agnus-castus], and AlloPure Green Tea^TM^ consisting of green tea leaf extract (Camellia sinensis) and phosphatidylcholine (from sunflower lecithin)
SLIMQUICK Pure Extra Strength Keto Complex | 670 mg: Medium Chain Triglycerides (MCT) Oil Powder, Caffeine, Chaste Tree fruit extract [Vitex agnus-castus], and KetoGreen^TM^ Green Tea consisting of green tea leaf extract (Camellia sinensis) and phosphatidylcholine (from sunflower lecithin)
SLIMQUICK Pure Extra Strength Gummies | 170 mg: Medium Chain Triglycerides (MCT) Oil Powder, Chromium, and KetoGreen^TM^ Green Tea consisting of green tea leaf extract (Camellia sinensis) and phospholipids (from sunflower lecithin)
SLIMQUICK Pure Extra Strength Keto Mixed Berry Drink | 385 mg: Caffeine, Medium Chain Triglycerides (MCT) Oil Powder, Chaste Tree fruit extract [Vitex agnus-castus], and KetoGreen^TM^ Green Tea consisting of green tea leaf extract (Camellia sinensis) and sunflower lecithin

### Hepatotoxicity

The initial reports of liver injury attributed to SLIMQUICK were published in 2012, with subsequent reports in 2014 and 2016, all from the United States. At least two dozen cases attributed to SLIMQUICK products have been described in the literature. These publications described an acute hepatocellular injury arising within 3 to 12 weeks of starting a SLIMQUICK product that contained green tea extract and caffeine along with several botanical extracts, the concentrations of which were not provided. The injury was moderate in severity and resolved within 1 to 2 months of stopping the dietary supplement (Case 1). At least one case resulted in need for emergency liver transplantation. Immunoallergic features were not present, but several patients had autoantibodies. Liver histology suggested drug induced liver injury rather than autoimmune hepatitis. The injury resolved once the nutritional supplement was stopped, but in some cases corticosteroids were used. Chronic or recurrent injury without reexposure did not occur.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The liver injury attributed to SLIMQUICK products has been attributed usually to green tea extract, but the mechanism by which this herb might cause liver injury is unexplained. Subsequent testing of cases of green tea liver injury have shown an association with HLA-B*35:01, an allele found in 10% to 12% of the general population but in more than 70% of cases attributed to green tea, including cases of SLIMQUICK associated liver injury. Indeed, this allele was found in more than 90% of cases of green tea injury that were considered highly likely or definitely related, but in only 66% of those that were considered only probably green tea related. Furthermore, 3 patients with recurrence of injury on re-exposure (sometimes to a different source of green tea) all had HLA-B*35:01. These findings suggest that green tea related liver injury is idiosyncratic in nature and likely to be immunologically mediated.

### Outcome and Management

The liver injury that has been attributed to SLIMQUICK products has usually been mild-to-moderate in severity and self-limited in course, resolving in 1 to 2 months of stopping the preparations. However, at least one case of acute liver failure requiring liver transplantation has been published. SLIMQUICK products have not been linked to instances of chronic hepatitis or vanishing bile duct syndrome. In patients presenting with acute, unexplained liver injury, all HDS products should be discontinued and the case reported to federal registries. It is also helpful to carefully define what products were being taken and at what doses and for how long. Retrieval of the actual product or products can also be helpful as progress is being made in the identification of ingredients by advanced chemical and biochemical methods. Testing for HLA-B*35:01 can help to further confirm the link to green tea. Patients with clinically apparent liver injury attributed to SLIMQUICK products should avoid other dietary supplements with green tea extract.

Drug Class: Herbal and Dietary Supplements, Multi-Ingredient Nutritional Supplements

## CASE REPORTS

### Case 1. Acute hepatitis attributed to use of a SLIMQUICK weight loss product.(1)

A 42 year old woman started a weight loss regimen using "Slim Quick Fat Burner" and developed nausea, anorexia, dark urine and jaundice 3 to 4 weeks later, leading her to stop the supplement. She had been in general good health and had no history of liver disease, alcohol use, drug allergies or risk factors for viral hepatitis. Her other medical problems (and medications) included hypertension (labetalol, hydrochlorothiazide and felodipine), hay fever and asthma (fexofenadine with pseudoephedrine), gastroesophageal reflux disease (esomeprazole) and depression (nortriptyline). She had taken these medications chronically and she continued them during the episode of jaundice. When first seen 5 days after stopping the weight loss powder, she was jaundiced. The BMI was 30.9 kg/m^2^. Laboratory tests showed a total bilirubin of 9.5 mg/dL (5.7 direct), ALT 1020 U/L, AST 923 U/L and alkaline phosphatase 190 U/L (R ratio=12.5). The serum albumin was 3.6 g/dL and INR 1.1. Tests for hepatitis A, B, C and E were negative. The ANA was strongly positive at 1: 1:1280, but SMA and AMA were negative. An abdominal ultrasound was normal except for slight hepatomegaly. She did not undergo liver biopsy and did not receive corticosteroids. She was hospitalized but for one day only. She began to improve soon after the weight loss product was stopped. Jaundice cleared within a month as did clinical symptoms. While serum ALT levels remained moderately elevated for 3 to 4 months, all liver tests were normal when she was seen 6 and 12 months after onset. Genetic testing revealed that she was HLA-B*35:01 heterozygous.(2) [Case #6 in Cited Reference 1.]

#### Key Points

Medication: | SLIMQUICK
Pattern: | Hepatocellular (R=12.5)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 1 month
Recovery: | Within 6 months
Other medications: | Labetalol, hydrochlorothiazide, felodipine, fexofenadine with pseudoephedrine, esomeprazole and nortriptyline, all taken chronically and continued

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
34 days | 5 | 1020 | 190 | 9.5 | Admission
35 days | 6 | 872 | 167 | 9.1
7 weeks | 2 weeks | 596 | 201 | 10.2 | INR 1.1
2 months | 1 month | 299 | 204 | 3.2
3 months | 2 months | 446 | 210 | 1.7
4 months | 3 months | 364 | 265 | 1.2
5 months | 4 months | 207 | 153 | 1.0
7 months | 6 months | 40 | 90 | 1.0 | Normal
1 year | 1 year | 33 | 76 | 1.0 | Normal
Normal Values | | <55 | <125 | <1.2

#### Comment

Green tea hepatotoxicity typically presents with jaundice and an acute viral hepatitis-like syndrome, and a markedly hepatocellular pattern of serum enzyme elevations and rapid improvement upon stopping. SLIMQUICK contains high concentrations of green tea extract, although formulations frequently change. Because SLIMQUICK, like many dietary supplements, is a brand of many products with many ingredients, it is difficult to implicate a specific ingredient of the product as the cause for liver injury. Other listed components of the SLIMQUICK Fat Burner product implicated included calcium, magnesium, silicon, caffeine, chaste tree extract, rhodiola, Japanese knotwood, brown seaweed, soy, uva-ursi, vitamins B6, B12, D, and K, folate, titanium, and cellulose. The finding that the patient was HLA-B*35:01 positive suggests that the injury was related to green tea.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

SLIMQUICK®

DRUG CLASS

Herbal and Dietary Supplements

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=SLIMQUICK)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Caffeine | 58-08-2 | C8-H10-N4-O2
Epigallocatechin Gallate (EGCG) (Green tea extract; Camellia sinensis) | 989-51-5 | C22-H18-O11

## CITED REFERENCE

1 Zheng EX, Rossi S, Fontana RJ, Vuppalanchi R, Hoofnagle JH, Khan I, Navarro VJ. (2016). Risk of liver injury associated with green tea extract in SLIMQUICK(®) weight loss products: results from the DILIN Prospective study. Drug Saf.
2 Hoofnagle JH, Bonkovsky HL, Phillips EJ, Li YJ, Ahmad J, Barnhart H, Durazo F, et al., Drug-Induced Liver Injury Network. (2020). HLA-B*35:01 and green tea induced liver injury. Hepatology.

## ANNOTATED BIBLIOGRAPHY

References updated: 03 September 2021

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; green tea and SLIMQUICK products are not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, but the specific herbals implicated were not listed).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry. Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, but SLIMQUICK products were not mentioned).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to HDS to a Swedish Registry found 31 with increased liver enzymes, 26 with elevated aminotransferase levels, 22 with mixed liver reaction and 12 with hepatitis; agents implicated in causing liver injury included valerian, ginseng, green tea, and aloe vera, but SLIMQUICK products were not specifically mentioned).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut; green tea and SLIMQUICK were not specifically mentioned).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbal and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, noni juice, Chinese herbs, vitamin A and anabolic steroids).
Weinstein DH, Twaddell WS, Raufman JP, Philosophe B, Mindikoglu AL. (2012). SlimQuick™ associated hepatotoxicity in a woman with alpha-1 antitrypsin heterozygosity. World J Hepatol. (24 year old woman developed fatigue and jaundice 3 months after starting SLIMQUICK [bilirubin 4.0 mg/dL, ALT 2615, Alk P 200 U/L, INR 1.2], with no improvement for 4 weeks after stopping, enzymes decreasing to normal within one month of starting prednisone which she was later able to stop and had normal liver tests in follow up; testing showed heterozygosity [MZ] of alpha-1-antitrypsin).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury discusses green tea hepatotoxicity, but does not specifically mention SLIMQUICK products).
Teschke R, Schulze J, Schwarzenboeck A, Eickhoff A, Frenzel C. (2013). Herbal hepatotoxicity: suspected cases assessed for alternative causes. Eur J Gastroenterol Hepatol. (Review of the literature of case series of suspected HDS related liver injury found evidence of other explanations for the liver injury in 19 of 23 publications involving 278 of 573 patients [49%], and that these other diagnoses weakened the causality assessment in most instances).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements, but none were attributed to green tea or a SLIMQUICK product).
Licata A, Macaluso FS, Craxì A. (2013). Herbal hepatotoxicity: a hidden epidemic. Intern Emerg Med. (Review and commentary on herbal hepatotoxicity discusses pyrrolizidine alkaloids, green tea, Echinacea, kava, usnic acid, ephedra and products made by Herbalife, Hydroxycut and LipoKinetix, but not SLIMQUICK).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and assessing causality; discusses cases of liver injury attributed to green tea, but does not specifically mention SLIMQUICK).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, 24 were attributed to green tea extracts and 6 implicated SLIMQUICK products).
Rossi S, Navarro VJ. (2014). Herbs and liver injury: a clinical perspective. Clin Gastroenterol Hepatol. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and assessing causality; discusses green tea hepatotoxicity but not specifically SLIMQUICK).
Navarro VJ, Lucena MI. (2014). Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and assessing causality; mentions green tea, but does not specifically discuss SLIMQUICK products).
Whitsett M, Marzio DH, Rossi S. (2014). SlimQuick™-Associated hepatotoxicity resulting in fulminant liver failure and orthotopic liver transplantation. ACG Case Rep J. (52 year old woman developed acute liver failure 3 weeks after taking SLIMQUICK for 2 days [bilirubin 16.5 mg/dL, ALT 945 U/L, Alk P 210 U/L, INR 2.82] and underwent successful liver transplantation shortly thereafter, the explant showing confluent necrosis).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver mentions that multi-ingredient supplements for weight loss have been implicated in many cases of liver injury).
Stickel F, Shouval D. (2015). Hepatotoxicity of herbal and dietary supplements: an update. Arch Toxicol. (Extensive review of liver injury due to HDS, discusses green tea hepatotoxicity, but does not specifically mention SLIMQUICK).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], of which 6 were attributed to SLIMQUICK products: see Navarro [2014] and Zheng [2016]).
Zheng EX, Rossi S, Fontana RJ, Vuppalanchi R, Hoofnagle JH, Khan I, Navarro VJ. (2016). Risk of liver injury associated with green tea extract in SLIMQUICK(®) weight loss products: results from the DILIN Prospective study. Drug Saf. (Among 899 cases of drug induced liver injury enrolled in a prospective study between 2004 and 2013, 6 [~1%] were attributed to a SLIMQUICK weight loss product, all were adult women, ages 22 to 58 who presented with hepatitis 12-66 days after starting SLIMQUICK [bilirubin 0.4 to 9.5 mg/dL, ALT 446 to 1732 U/L, Alk P 81-239 U/L], 5 were jaundiced, 3 hospitalized, 1 required liver transplantation, the remaining recovering after stopping).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by Dietary Supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products including more than 50 attributed to green tea which is a constituent of many commercial weight loss supplements including SLIMQUICK [Weinstein 2012, Whislett 2014]).
Roytman MM, Poerzgen P, Navarro V. (2018). Botanicals and hepatotoxicity. Clin Pharmacol Ther. (Review of the hepatotoxicity and clinical features of injury caused by botanical agents including green tea, OxyELITE Pro and anabolic steroids).
EFSA Panel on Food Additives and Nutrient Sources added to Food (ANS), Younes M, Aggett P, Aguilar F, Crebelli R, Dusemund B, Filipič M, Frutos MJ, et al. Scientific opinion on the safety of green tea catechins. EFSA J 2018; 16: e05239. (Review of the literature by an expert panel concluded that green tea infusions and drinks should be considered “generally as safe”, although there are rare instances of associated liver injury which are probably idiosyncratic reactions, but that doses of green tea extracts equivalent to 800 mg of EGCG or more daily can be associated with significant aminotransferase elevations).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] although none were attributed specifically to a SLIMQUICK product).
Oketch-Rabah HA, Roe AL, Rider CV, Bonkovsky HL, Giancaspro GI, Navarro V, Paine MF, et al. (2020). United States Pharmacopeia (USP) comprehensive review of the hepatotoxicity of green tea extracts. Toxicol Rep. (An extensive review of the chemistry and potential toxicity of green tea concluded that green tea was a rare cause of liver injury and that it should be labeled with a warning).
Hoofnagle JH, Bonkovsky HL, Phillips EJ, Li YJ, Ahmad J, Barnhart H, Durazo F, et al., Drug-Induced Liver Injury Network. (2020). HLA-B*35:01 and green tea induced liver injury. Hepatology. (Among 1414 cases of drug induced liver injury enrolled in a prospective US database between 2004 and 2018, 273 were attributed to HDS, of which 40 were judged to be due to green tea, often as a part of a multi-ingredient product [SLIMQUICK being the second most frequently implicated commercial product, n=5], with a median latency of 42 days and hepatocellular injury [95%], which was severe in 35% and led to liver transplantation in 8%; 3 patients had documented recurrence upon re-exposure; HLA-B*35:01 was present in 72% of green tea cases [80% of those attributed to SLIMQUICK] versus 11-15% of controls, suggesting an immunologic pathogenesis).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2021:S1542-3565(21)00013-6. Epub ahead of print. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], although none to listed as specifically a SLIMQUICK product).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Hou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; the commercial names [such as SLIMQUICK] of the products with green tea ingredients were not provided).

## OTHER REFERENCE LINKS

1 Recent References on SLIMQUICK: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(SLIMQUICK/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on SLIMQUICK: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=SLIMQUICK&Search=Search)